# Covid-19 Monoclonal Antibodies

[underlined: Monoclonal Antibodies to SARS-CoV-2]

## OVERVIEW

### Introduction

The severe acute respiratory syndrome coronavirus type 2 (SARS-CoV-2) is a novel coronavirus that arose in late 2019 and led to a worldwide pandemic of respiratory illness (COVID-19) and, within the first year of its recognition, led to more than 100 million infections and at least 2 million deaths worldwide. SARS-CoV-2 is a large, single-stranded RNA virus which encodes four structural proteins: spike (S), membrane (M), envelop (E) and nucleocapsid (N). The virus binds to the angiotensin-converting enzyme 2 (ACE2) protein on the surface of cells, the binding region on the surface of the virus being the spike protein. Upon binding, the spike protein undergoes structural rearrangement, losing a protein subunit and inserting a fusion peptide into the host cell membrane through which the virus RNA is inserted. Antibodies to the SARS-CoV-2 spike protein have been shown to be neutralizing, to block fusion and insertion of the viral RNA and to prevent infection. Vaccines for COVID-19 have focused on inducing antibodies to the spike protein. In addition, monoclonal antibodies to the receptor binding domain of the SARS-CoV-2 spike protein have been developed and shown to neutralize virus in vitro and in vivo in animal models when given before or at the time of exposure to the virus. Controlled trials of these monoclonal antibodies have demonstrated their ability to lessen the severity of COVID-19 infection when given early in the course of infection in patients with high risk of progressive disease. Trials in patients exposed but not yet infected with SARS-CoV-2 have shown there efficacy in preventing infection and disease in high risk individuals (at least for some monoclonal antibody combinations). At the same time, these monoclonal antibodies which are given intravenously or by subcutaneous injection are well tolerated. There is no evidence that any of the anti-SARS-CoV-2 monoclonal antibodies cause serum enzyme elevations or clinically apparent liver injury.

### Background

Monoclonal antibodies to the spike protein of the SARS-CoV-2 virus have been developed and several have been shown to have neutralizing activity in vitro in cell culture as well as in vivo in animal models of COVID-19 infection. In clinical trials, administration of one or more of these monoclonal antibodies have been associated with a decrease in disease progression, particularly if given early in the course of illness in persons at high risk of disease progression. By the end of 2021, 5 monoclonal antibodies have been given Emergency Use Authorization (EUA) in the United States, but the changing frequency of circulating variants of SARS-CoV-2 has changed the generalizability of their efficacy. Four of the monoclonal antibodies are recommended to be given only in combination: bamlanivimab (LY-CoV555) and etesevimab (LY-CoV016); or casirivimab (REGN10933) and imdevimab (REGN10987), the combination known as REGN-COV2. However, both of these combination regimens are now rarely used because of their lack of neutralizing activity against the Omicron variant of SARS-CoV-2, which became the major circulating variant in the United States and much of the world by early 2022. The fifth monoclonal antibody to receive EUA in the United States was sotrovimab (VIR-7831). Unlike the other monoclonal antibodies given EUA, sotrovimab appears to bind to the Spike protein but rather than preventing its binding to the ACE-2 receptor, prevents the subsequent activity of the virus to insertion of a fusion protein and inject viral RNA into the cell. While apparently effective against the initial Omicron variant of SARS-CoV-2, sotrovimab had little or no activity against the Omicron BA.2 sub-variant and its authorization was subsequently withdrawn.

Current indications for use of monoclonal antibodies to SARS-CoV-2 are for nonhospitalized adults with confirmed COVID-19 infection, but without need for supplemental oxygen who are at high risk for complications. These therapies should be administered as soon as possible and at most 10 days after onset of symptoms or diagnosis. In patients with more advanced infection, the monoclonal antibodies had little or no effect on clinical outcome and may be harmful. While some regimens of monoclonal antibodies have shown efficacy in post-exposure prophylaxis (in high risk subjects with known close exposure to a case of COVID-19), not all have been evaluated in this situation. Most monoclonal antibodies to SARS-CoV-2 are given as a single intravenous infusion and require administration in a clinical setting where there is experience in administering intravenous infusions and in managing allergic reactions. The dosage and regimen of administration should be carefully followed. Recommendations and guidelines on management of COVID-19 change frequently. Current guidelines with information on indications and doses of monoclonal antibodies to SARS-CoV-2 are provided by the following frequently updated websites.

NIH Treatment Guidelines on management of COVID-19.

https://www.covid19treatmentguidelines.nih.gov/overview/

European Medicines Agency on management of COVID-19.

https://www.ema.europa.eu/en/human-regulatory/overview/public-health-threats/coronavirus-disease-covid-19/covid-19-latest-updates

### Hepatotoxicity

In trials of monoclonal antibodies to the COVID-19 spike protein there have been no reports of ALT elevations or hepatotoxicity. Side effects may include rash and diarrhea and, in rare instances, hypersensitivity reactions.

Likelihood score, all five monoclonal anti-SARs-CoV-2 antibodies: E (unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

Monoclonal antibodies have no specific hepatic metabolism and are broken down in cells to amino acids. The mechanism by which they might cause liver injury is unknown.

Drug Class: Monoclonal Antibodies, Antiviral Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bamlanivimab® (LY-CoV555)

Etesevimab® (LY-CoV016)

Casirivimab® (REGN10933)

Imdevimab® (REGN10987)

Sotrovimab® (VIR-7831)

DRUG CLASS

Monoclonal Antibodies

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bamlanivimab) – Bamlanivimab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Etesevimab) – Etesevimab

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Casirivimab) – REGN-COV2^TM^ (Casirivimab with Imdevimab)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Sotrovimab) – Sotrovimab

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bamlanivimab | 2423943-37-5 | Monoclonal Antibody | Not Available
Etesevimab | 2423948-94-9 | Monoclonal Antibody | Not Available
Casirivimab | 2415933-42-3 | Monoclonal Antibody | Not Available
Imdevimab | 2415933-40-1 | Monoclonal Antibody | Not Available
Sotrovimab | 2423014-07-5 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 31 January 2022

Chen P, Nirula A, Heller B, Gottlieb RL, Boscia J, Morris J, Huhn G, et al. (2021). BLAZE-1 Investigators. SARS-CoV-2 neutralizing antibody LY-CoV555 in outpatients with Covid-19. N Engl J Med. (Among 452 patients with mild or moderate COVID-19 treated with a single iv infusion of bamlanivimab [LY-CoV555: 700, 2800 or 7000 mg] or placebo, there was more rapid resolution of symptoms and fewer COVID-19 related hospitalizations [1.6% vs 6.3%] in those receiving monoclonal antibody, while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Weinreich DM, Sivapalasingam S, Norton T, Ali S, Gao H, Bhore R, Musser BJ, et al. (2021). Trial Investigators. REGN-COV2, a neutralizing antibody cocktail, in outpatients with Covid-19. N Engl J Med. (Among 275 nonhospitalized patients with COVID-19 treated with a single iv infusion of REGN-COV2 [equal doses of casirivimab and imdevimab, 2.4 or 8.0 gm] or placebo, there were fewer subsequent COVID-19 related medically-attended visits [3% vs 6%] in those receiving monoclonal antibody, while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
(2020). An EUA for bamlanivimab – a monoclonal antibody for COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of monotherapy with bamlanivimab in patients with mild-to-moderate COVID-19 who are at high risk of progressing to more severe disease shortly after its emergency use authorization by the FDA on November 9, 2020; no mention of ALT elevations or hepatotoxicity).
(2020). An EUA for casirivimab and imdevimab for COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of the combination of casirivimab and imdevimab for patients with mild-to-moderate COVID-19 [age 12 years or above; weight at least 40 kg] at high risk of progressing to more severe disease shortly after its emergency use authorization on November 9 2020; mentions that infusion reactions occur and one case of anaphylaxis has been reported; no mention of ALT elevations or hepatotoxicity).
ACTIV-3/TICO LY-CoV555 Study Group, Lundgren JD, Grund B, Barkauskas CE, Holland TL, Gottlieb RL, Sandkovsky U, Brown SM, et al. A neutralizing monoclonal antibody for hospitalized patients with Covid-19. N Engl J Med 2021; 384: 905-14. (Among 314 adult patients hospitalized with COVID-19 without end-organ failure treated with intravenous bamlanivimab [LY-CoV555: 7000 mg] or placebo, time to recovery and rates of deterioration and death were similar in the two groups as were adverse event rates; no mention of ALT elevations or hepatotoxicity).
Gottlieb RL, Nirula A, Chen P, Boscia J, Heller B, Morris J, Huhn G, et al. (2021). Effect of bamlanivimab as monotherapy or in combination with etesevimab on viral load in patients with mild to moderate COVID-19: a randomized clinical trial. JAMA. (Among 577 patients treated with a single infusion of bamlanivimab alone [700, 2800 or 7000 mg] or combined with etesevimab [2800 and 2800 mg], or placebo, the change in viral levels by day 11 was significant only for the combination, while subsequent emergency room visits or hospitalizations were less with monotherapy [1% to 2%] and combination therapy [1%] vs placebo [5.8%], while adverse event rates were similar in the two groups, immediate hypersensitivity reactions occurring in 2% vs 0.6%).
Rizk JG, Forthal DN, Kalantar-Zadeh K, Mehra MR, Lavie CJ, Rizk Y, Pfeiffer JP, et al. (2021). Expanded Access Programs, compassionate drug use, and Emergency Use Authorizations during the COVID-19 pandemic. Drug Discov Today. (Review of the FDA Expanded Assess Program [EAP: for ruxolitinib and convalescent plasma] and Emergency Use Authorization [for hydroxychloroquine and chloroquine, convalescent plasma, remdesivir, baricitinib, bamlanivimab, casirivimab, and imdevimab] during 2020 in response to the COVID-19 pandemic).
Focosi D, Maggi F. (2021). Neutralising antibody escape of SARS-CoV-2 spike protein: risk assessment for antibody-based Covid-19 therapeutics and vaccines. Rev Med Virol. (Review of the antibody escape mutations in the spike protein of SARS-CoV-2 [including the so-called UK -B.1.1.7, South African -B.1.351 – and Brazilian -P.1- strains] and their clinical significance in regard to efficacy of COVID vaccines and monoclonal antibodies).
(2021). An EUA for bamlanivimab and etesevimab for COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and availability of the combination of bamlanivimab and etesevimab administered together for patients with mild-to-moderate COVID-19 who are 12 years old or more [weighing at least 40 kg] and at high risk of progressive disease mentions that hypersensitivity reactions have occurred with bamlanivimab therapy; no mention of ALT elevations or hepatotoxicity).
Hoffmann M, Arora P, Groß R, Seidel A, Hörnich BF, Hahn AS, Krüger N, et al. (2021). SARS-CoV-2 variants B.1.351 and P.1 escape from neutralizing antibodies. Cell. (Using a pseudotyped VSV model of SARS-CoV-2 entry, casirivimab/imdevimab and bamlanivimab blocked entry of standard strains and the mutant B.1.1.7 [UK] strains, but casirivimab and bamlanivimab alone were minimally effective against the B.1.351 [South African] and P.1 [Brazilian] variants).
Jones BE, Brown-Augsburger PL, Corbett KS, Westendorf K, Davies J, Cujec TP, Wiethoff CM, et al. The neutralizing antibody, LY-CoV555, protects against SARS-CoV-2 infection in nonhuman primates. Sci Transl Med. 2021;13(593):eabf1906. (In a Cynomolgus macaque [rhesus monkey] model of SARS-CoV-2 infection, preadministration of bamlanivimab reduced viral replication in both upper and lower respiratory tract).
Hurt AC, Wheatley AK. (2021). Neutralizing antibody therapeutics for COVID-19. Viruses. (Review of the efficacy and safety of monoclonal antibodies to SARS-CoV-2 spike protein as therapy of patients with early COVID-19 infection and as postexposure prophylaxis mentions early results of ongoing trials suggesting that administration of monoclonal antibodies reduced subsequent clinically apparent infections by 80-100% without serious adverse events).
Kumar RN, Wu EL, Stosor V, Moore WJ, Achenbach C, Ison MG, Angarone MP. (2022). Real-world experience of bamlanivimab for coronavirus disease 2019 (COVID-19): A case-control study. Clin Infect Dis. (Among 303 nonhospitalized high risk patients or medical care personnel with symptomatic COVID-19 infection referred for bamlanivimab therapy, hospitalization rates were lower in the 218 who received the monoclonal antibody [7.3%] than in the 185 who did not [20%] as were rates of ICU admission [0.9% vs 2.7%] and death [0.5% vs 2.2%], and there were no serious adverse events).
(2021). An EUA for sotrovimab for treatment of COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of sotrovimab shortly after its approval for treatment of outpatients diagnosed with COVID-19 who were at high risk for complications, mentions mild complications of rash [2%] and diarrhea [1%], but does not mention ALT elevations or hepatotoxicity).
(2021). Bamlanivimab and etesevimab for post-exposure prophylaxis of COVID-19. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of the combination of bamlanivimab and etesevimab as post-exposure prophylaxis against hospitalization or death in persons at high risk of complications of COVID-19 who had an exposure to a patient with known infection, shortly after the expansion of indications for these monoclonal antibodies; no mention of ALT elevations or hepatotoxicity).
Gupta A, Gonzalez-Rojas Y, Juarez E, Crespo Casal M, Moya J, Falci DR, Sarkis E, et al. (2021). COMET-ICE Investigators. Early treatment for Covid-19 with SARS-CoV-2 neutralizing antibody sotrovimab. N Engl J Med. (Among 583 adults with symptomatic COVID-19 treated with sotrovimab or placebo as a single intravenous infusion within 5 days of onset, hospitalization or death occurred in 7% of placebo vs 1% of monoclonal antibody recipients; while adverse event rates were similar, severe event rates were less with therapy, none of which were liver related).
CDC. (2021). COVID-19 Response Team. SARS-CoV-2 B.1.1.529 (Omicron) Variant – United States, December 1-8, 2021. MMWR Morb Mortal Wkly Rep. (Mentions that the first report of Omicron [Variant of Concern: B.1.1.529] related COVID-19 was from South Africa in late November 2021, and the first case in the US on December 1, 2021; yet 43 cases from 21 states were identified by December 8^th,^ most cases being clinically mild and many occurring in fully vaccinated and even boosted individuals).
ACTIV-3/Therapeutics for Inpatients with COVID-19 (TICO) Study Group. Efficacy and safety of two neutralising monoclonal antibody therapies, sotrovimab and BRII-196 plus BRII-198, for adults hospitalised with COVID-19 (TICO): a randomised controlled trial. Lancet Infect Dis. 2021:S1473-3099(21)00751-9. (Among 584 adults hospitalized with COVID-19 pneumonia treated with sotrovimab, a mixture of two experimental anti-SARS-CoV-2 monoclonal antibodies, or placebo, there were no differences in rates of serious complications or death [7% with placebo, 9% with 2 monoclonals, 8% with sotrovimab], and there were no liver related serious adverse events).
Cameroni E, Bowen JE, Rosen LE, Saliba C, Zepeda SK, Culap K, Pinto D, et al. (2021). Broadly neutralizing antibodies overcome SARS-CoV-2 Omicron antigenic shift. Nature. (The Omicron variant of SARS-CoV-2 encodes a 37 amino acid substitution in the spike protein and is resistant to most monoclonal antibodies in use except for sotrovimab, which binds to the spike protein outside of the receptor binding motif which is the target recognized by most other monoclonals).
Johnson AG, Amin AB, Ali AR, Hoots B, Cadwell BL, Arora S, Avoundjian T, et al. (2022). COVID-19 Incidence and death rates among unvaccinated and fully vaccinated adults with and without booster doses during periods of Delta and Omicron variant emergence – 25 U.S. jurisdictions, April 4-December 25, 2021. MMWR Morb Mortal Wkly Rep. (Infection and death rates in the US among vaccinated and unvaccinated adults during 2021 demonstrated an increase in COVID-19 cases due to the Omicron variant [to 75% in late December] and a markedly lower mortality rate among vaccinees, particularly those who received a booster dose).
(2022). Monoclonal antibodies to COVID-19. Med Lett Drugs Ther. (Concise report that the monoclonal antibody combinations of casirivimab with imdevirmab [REGEN-COV] and bamlanivimab with etesevimab have little activity against the Omicron variant of SARS-CoV-2 and should not be used, the only monoclonal antibody with activity against the currently predominant virus being sotrovimab).

## OTHER REFERENCE LINKS

1 Recent References on Bamlanivimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bamlanivimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bamlanivimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bamlanivimab)
3 Recent References on Etesevimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Etesevimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
4 Trials on Etesevimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Etesevimab)
5 Recent References on Casirivimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Casirivimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
6 Trials on Casirivimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Casirivimab)
7 Recent References on Imdevimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Imdevimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
8 Trials on Imdevimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Imdevimab)
9 Recent References on Sotrovimab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sotrovimab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
10 Trials on Sotrovimab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sotrovimab)